# Coenzyme Q10

## OVERVIEW

### Introduction

Coenzyme Q10, also known as ubiquinone, is an enzyme cofactor found in virtually all cells of the body and participates in many essential energy-producing and antioxidant enzymatic actions. While normally synthesized in the body in adequate amounts, coenzyme Q10 is used as a nutritional supplement for conditions highly dependent upon its actions, some of which are associated with low serum levels of the coenzyme. Coenzyme Q supplements are generally well tolerated and there is no evidence that they cause serum enzyme elevations or clinically apparent liver injury.

### Background

Coenzyme Q10, also known as ubiquinone, is an enzyme cofactor found in virtually all cells of the body where it participates in essential energy-producing and antioxidant actions. Coenzyme Q10 is a fat-soluble vitamin K-like molecule that is found in highest concentrations in the heart, liver, kidney, and brain. It is an essential component of the respiratory chain in mitochondria where it acts as an oxygen acceptor during the production of adenosine triphosphate (ATP), the molecule used in all energy requiring metabolic reactions. Coenzyme Q10 has multiple critical cellular actions: it is an essential antioxidant, is required for energy conversion, and also stimulates cell growth and inhibits cell death. Because of its multiple actions and essential role in oxidative metabolism, coenzyme Q10 has been purposed as a means of preventing or ameliorating many medical conditions, including migraine headaches, Parkinson’s disease, Huntington chorea, heart failure, hypertension, statin induced myalgias and myopathy, and even fatty liver disease. While preclinical and pilot clinical studies have demonstrated evidence of benefit from supplementation with coenzyme Q10, larger, more rigorously controlled clinical trials have failed to show definite evidence of its benefit in any of these conditions, and it is not approved by the FDA for any disease or medical condition. Nevertheless, the antioxidant effects and essential nature of coenzyme Q10 in metabolism makes it an attractive candidate for ameliorating otherwise poorly controlled conditions. Coenzyme Q10 is widely used and is available in multiple over-the-counter generic forms as tablets, capsules, gelcaps, wafers, and in liquid solution. Because it is lipid soluble, it is frequently given with lipids or vitamin E to improve absorption. The typical dose is 300 to 1200 mg in divided doses daily. Coenzyme Q10 is well tolerated even in high doses with side effect rates no higher than with placebo. Side effects are largely non-specific symptoms of gastrointestinal upset, nausea, headache, dizziness, and fatigue. They are usually mild and short-lived, rarely requiring dose adjustment or discontinuation. Serious adverse events are rare and usually considered unrelated. Long term use has not been associated with disease complications or cancer.

Q refers to the quinone ring which is the active catalytic site of the coenzyme; 10 refers to the 10 isoprene units that make up the long tail of the molecule. Coenzyme Q10 is somewhat similar in structure to vitamin K.

### Hepatotoxicity

Coenzyme Q10 is generally recognized as safe and has not been linked to elevations in serum aminotransferase, alkaline phosphatase, or bilirubin levels. Despite wide scale use for several decades, there have been no convincing reports of clinically apparent liver injury due to coenzyme Q10.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Drug Class: Nutritional Supplements

Other Names: Ubiquinone, Semiubiquinone, Ubiquinol, CoQ10

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Coenzyme Q10 – Generic

DRUG CLASS

Nutritional Supplements

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Coenzyme Q10 | 303-98-0 | C59-H90-O4
Vitamin K | 84-80-0 | C31-H46-O2

## SELECTED ANNOTATED BIBLIOGRAPHY

References updated: 20 April 2024

Abbreviations: HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal and dietary supplements are discussed, but not coenzyme Q10).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity of herbal and dietary supplements [HDS] published in 2007; no mention of coenzyme Q10).
Coenzyme Q10. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 958-961. (Compilation of short monographs on herbal medications and dietary supplements, mentions that coenzyme 10 “has a very low toxicity profile” and has “no reports of overt hepatotoxicity”).
Crane FL. Biochemical functions of coenzyme Q10. J Am Coll Nutr. 2001;20:591-8. (Review of the biochemistry of coenzyme Q10 which is an essential component in mitochondria for oxidative phosphorylation and production of ATP from carbohydrates and fatty acids; but it also participates in other enzyme activity, with antioxidant effects in cell membranes, maintenance of redox homeostasis and serves functions in cell membranes with antioxidant effects, maintenance of redox potential, and control of membrane channels and participating in other enzymatic synthetic functions). 11771674
Shults CW, Oakes D, Kieburtz K, Beal MF, Haas R, Plumb S, Juncos JL, et al.; Parkinson Study Group. Effects of coenzyme Q10 in early Parkinson disease: evidence of slowing of the functional decline. Arch Neurol. 2002;59:1541-50. (Among 80 patients with early Parkinson disease treated with coenzyme Q10 [300, 600, or 1200 mg) or placebo daily for 16 months, worsening of Parkinson disease rating scales was less with the highest dose of coenzyme Q10, but worsening was similar with placebo as overall with the 3 drug doses; the drug was well tolerated and adverse event rates including laboratory abnormalities were similar in all 4 groups). 12374491
Hidaka T, Fujii K, Funahashi I, Fukutomi N, Hosoe K. Safety assessment of coenzyme Q10 (CoQ10). Biofactors. 2008;32(1-4):199-208. (Review of safety data from animal and human studies of coenzyme Q10 concludes that it has “low toxicity” and “does not induce serious adverse events in humans” in doses of up to 1200 mg daily, common adverse events being generally mild, including stomach upset, nausea, diarrhea, headache, heartburn, and fatigue while changes in laboratory biochemistry were not dose related, not clinically significant, and similar in frequency to changes observed in placebo recipients). 19096117
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf 2009; 18: 1039-47. (Among 778 spontaneous reports of adverse reactions to herbal and alterative medicines to a national Swedish Registry, coenzyme Q10 was the implicated agent in 42 [5%], the reaction being “mixed liver reaction” in 2, but no details provided). 19650152
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012; 32: 1543-56. (A systematic compilation of all publications on the hepatotoxicity of specific herbal products identified 185 publications on 60 different herbs, herbal drugs and supplements but does not mention coenzyme Q10). 22928722
Navarro VJ, Seeff LB. Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis 2013; 17: 715-35. (Review of the epidemiology, regulatory status, diagnosis, pathogenesis and causes of liver injury from herbal products with specific discussion of conjugated linoleic acid, ephedra, germander, green tea, usnic acid, flavocoxid, aloe vera, chaparral, greater celandine, black cohosh, comfrey, kava, skullcap, valerian, noni juice, pennyroyal, and traditional herbal remedies but does not mention coenzyme Q10). 24099027
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60: 1399-408. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products but does not mention coenzyme Q10). 25043597
Parkinson Study Group QE3 Investigators; Beal MF, Oakes D, Shoulson I, Henchcliffe C, Galpern WR, Haas R, Juncos JL, et al. A randomized clinical trial of high-dosage coenzyme Q10 in early Parkinson disease: no evidence of benefit. JAMA Neurol. 2014;71:543-52. (Among 600 patients with Parkinson disease treated with coenzyme Q10 [1200 or 2400 mg] or placebo daily for 16 months, worsening of the disease rating scales were similar in all 3 groups as were adverse event rates [2.5% vs 2.0%]). 24664227
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107: 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products does not mention coenzyme Q10). 27402097
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al.; Spanish DILI Registry. Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. 2018;16:1495-1502. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal and dietary supplements, the most frequent cause being green tea [n=8] and Herbalife products [n=6]; no mention of coenzyme Q10). 29307848
Ayers J, Cook J, Koenig RA, Sisson EM, Dixon DL. Recent developments in the role of coenzyme Q10 for coronary heart disease: a systematic review. Curr Atheroscler Rep. 2018;20:29. (Systematic review of controlled clinical trials of coenzyme Q10 in coronary artery disease including studies in statin related myalgias, chronic heart failure, hypertension, hyperlipidemia, and glycemic control concluded that evidence does not support its use, although it appears to be associated with minimal adverse events; no mention of ALT elevations or hepatotoxicity). 29766349
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. Herb-induced liver injury: systematic review and meta-analysis. World J Clin Cases. 2021;9:5490-5513. (Systematic review of the literature on HDS induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62], and greater celandine [48]; does not mention coenzyme Q10). 34307603
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. 2022;20:e548-e563. (Among 367 cases of hepatotoxicity enrolled in the Latin American Drug-Induced Liver Injury Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5], and garcinia [n=3]; no mention of coenzyme Q10). 33434654
Hansen KS, Mogensen TH, Agergaard J, Schiøttz-Christensen B, Østergaard L, Vibholm LK, Leth S. High-dose coenzyme Q10 therapy versus placebo in patients with post COVID-19 condition: a randomized, phase 2, crossover trial. Lancet Reg Health Eur. 2023;24:100539. (Among 121 adults with symptomatic post-COVID syndrome treated with coenzyme Q10 [100 mg] or placebo five times daily for 6 weeks with a crossover after a 4-week washout period, symptoms improved in both groups equally and adverse events were uncommon and mild, mostly diarrhea and nonspecific symptoms; no mention of ALT elevations or hepatotoxicity). 36337437

## OTHER REFERENCE LINKS

Recent References on Coenzyme Q10: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Coenzyme+Q10+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Coenzyme Q10: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Coenzyme%20Q10)